# Denosumab

## OVERVIEW

### Introduction

Denosumab is a monoclonal antibody to the RANK ligand which plays an important role in bone remodeling. Denosumab is used in the therapy of osteoporosis and for bone metastases and rare bone tumors. Denosumab therapy has not been associated with serum enzyme elevations during therapy, nor has it been convincingly implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Denosumab (den oh’ sue mab) is a recombinant, human monoclonal IgG2 antibody to the ligand for RANK (receptor activator of NF kappa B) which plays an important role in bone remodeling and stimulates differentiation, maturation and activation of bone osteoclasts. Inhibition of the RANK ligand (RANK-L) inhibits osteoclast activity and increases bone density by the lessen osteoclast and the unopposed osteoblast activity. Treatment with denosumab has been shown to increase bone mineral density scores as assessed by DEXA scan, and long term therapy has been associated with a lower rate of bone fractures. Denosumab was approved for use in the United States in 2010, and current indications are for men and postmenopausal women with osteoporosis at increased risk for bone fractures and for men with reduced bone mineral density on antiandrogen and women on antiestrogen therapy. Denosumab has also been approved for use in patients with bone metastases from solid tumors and in giant cell tumor of bone. For treatment of osteoporosis, denosumab is available in single use vials or prefilled syringes of 60 mg under the brand name Prolia. The recommended dose is 60 mg subcutaneously every 6 months. Denosumab is also available in single use vials of 120 mg (70 mg/mL) for malignant bone disease under the brand name of Zgeva. The recommended dose for bone metastases is 120 mg subcutaneously every 4 weeks. More frequent dosing is used initially in treating giant cell tumor of bone. All patients receiving denosumab should also take oral calcium (1000 mg) and vitamin D (400 IU) daily. Side effects of denosumab are uncommon, but can include injection site reactions, back and join pains, rash, diarrhea, nausea and vomiting and headache. Rare side effects include severe infusion reactions, hypersensitivity reactions, anaphylaxis, hypocalcemia, osteonecrosis of the jaw and atypical femoral fractures.

### Hepatotoxicity

In large clinical trials, denosumab was not associated with changes in serum aminotransferase levels during therapy and rates of most adverse reactions were similar in patients who received denosumab as placebo. Since its approval and more wide-scale use, it has been implicated in only one instance of clinically apparent acute liver injury which resulted in chronic injury that was responsive to corticosteroid therapy and likely represented an unrelated onset of autoimmune liver disease. Thus, significant liver injury from denosumab must be very rare, if it occurs at all.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Denosumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. The RANK ligand pathways are important in bone turnover and formation. RANK is found on the surface of marrow stromal cells and on activated T cells, but its engagement by ligand has no recognized effect on the liver. However, its engagement of immunocytes suggests that it might lead to a self-perpetuating autoimmune condition such as autoimmune hepatitis.

Drug Class: Osteoporosis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Denosumab – Prolia®, Xgeva®

DRUG CLASS

Osteoporosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Denosumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Denosumab | 615258-40-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; denosumab is not specifically mentioned).
Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1275-1306. (Textbook of pharmacology and therapeutics).
McClung MR, Lewiecki EM, Cohen SB, Bolognese MA, Woodson GC, Moffett AH, Peacock M, et al; AMG 162 Bone Loss Study Group. Denosumab in postmenopausal women with low bone mineral density. N Engl J Med 2006; 354: 821-31. (Among 412 postmenopausal women with low bone density treated with denosumab [3 doses every 3 or 6 months], alendronate or placebo for 12 months, bone density increased with denosumab and alendronate but not placebo, and there were "no clinically relevant changes" in blood chemistry results). 16495394
Lipton A, Steger GG, Figueroa J, Alvarado C, Solal-Celigny P, Body JJ, de Boer R, et al. Randomized active-controlled phase II study of denosumab efficacy and safety in patients with breast cancer-related bone metastases. J Clin Oncol 2007; 25: 4431-7. (Among 255 women with breast cancer and bone metastases treated with denosumab for at least 13 weeks, there were no "unexpected" changes in liver enzymes). 17785705
Lewiecki EM, Miller PD, McClung MR, Cohen SB, Bolognese MA, Liu Y, Wang A, et al.; AMG 162 Bone Loss Study Group. Two-year treatment with denosumab(AMG 162) in a randomized phase 2 study of postmenopausal women with low BMD. J Bone Miner Res 2007; 22: 1832-41. (Continued follow-up of 412 women treated with denosumab, alendronate or placebo [McClung 2006]; the incidence of side effects was similar in all three groups and not changed during the second year of the study, and there were "no clinically relevant changes in either serum chemistry or hematology values"). 17708711
Cummings SR, San Martin J, McClung MR, Siris ES, Eastell R, Reid IR, Delmas P, et al.; FREEDOM Trial. Denosumab for prevention of fractures in postmenopausal women with osteoporosis. N Engl J Med 2009; 361: 756-65. (Among 7868 postmenopausal women with osteoporosis treated with denosumab or placebo [every 6 months] for 3 years, bone mineral increased and fractures were less in the denosumab treated patients, while rates of most adverse events were similar except for eczema [3% vs 1.7%], cellulitis [0.3% vs <0.1%] and flatulence [2.2% vs 1.4%]; no mention of ALT elevations or hepatotoxicity). 19671655
Denosumab (Prolia) for postmenopausal osteoporosis. Med Lett Drugs Ther. 2010 Oct 18; 52 (1349): 81-2. (Concise review of mechanism of action, efficacy, safety and costs of denosumab shortly after its approval in the US mentions that adverse effects may include hypocalcemia and rash and more rarely infections, pancreatitis, malignancies and osteonecrosis, but does not mention ALT elevations or hepatotoxicity). 21045756
Denosumab for bone metastases. Med Lett Drugs Ther 2011; 53 (1356): 8. (Short description of expansion of indications for denosumab to include bone metastases). 21252843
Dore RK. The RANKL pathway and denosumab. Rheum Dis Clin North Am 2011; 37: 433-52, vi-vii. (Review of the role of RANK pathway in bone remodeling and mechanism of action, efficacy and safety of denosumab). 22023901
Orwoll E, Teglbjærg CS, Langdahl BL, Chapurlat R, Czerwinski E, Kendler DL, Reginster JY, et al. A randomized, placebo-controlled study of the effects of denosumab for the treatment of men with low bone mineral density. J Clin Endocrinol Metab 2012; 97: 3161-9. (Among 242 men with low bone mineral density treated with denosumab or placebo for 1 year, denosumab led to increases in bone density, but no difference in side effects compared to placebo; no mention of ALT levels or hepatotoxicity). 22723310
Bone HG, Chapurlat R, Brandi ML, Brown JP, Czerwinski E, Krieg MA, Mellström D, et al. The effect of three or six years of denosumab exposure in women with postmenopausal osteoporosis: results from the FREEDOM extension. J Clin Endocrinol Metab 2013; 98: 4483-92. (Among 3547 postmenopausal women with osteoporosis treated with denosumab for 3 or 6 years, efficacy was sustained with long term use while side effects did not increase with time; no mention of ALT elevations or hepatotoxicity). 23979955
Chawla S, Henshaw R, Seeger L, Choy E, Blay JY, Ferrari S, Kroep J, et al. Safety and efficacy of denosumab for adults and skeletally mature adolescents with giant cell tumour of bone: interim analysis of an open-label, parallel-group, phase 2 study. Lancet Oncol 2013; 14: 901-8. (Among 282 patients with giant cell tumor of bone treated with denosumab for an average of 10 months, side effects were uncommon, but included arthralgias, headache, nausea, fatigue, back pain, low phosphate and calcium [5%]; no mention of ALT elevations or hepatotoxicity). 23867211
Recknor C, Czerwinski E, Bone HG, Bonnick SL, Binkley N, Palacios S, Moffett A, et al. Denosumab compared with ibandronate in postmenopausal women previously treated with bisphosphonate therapy: a randomized open-label trial. Obstet Gynecol 2013; 121: 1291-9. (Among 833 postmenopausal women with osteoporosis who were treated with denosumab [every 6 months] or ibandronate [monthly] for 12 months, bone density increased more with denosumab; no mention of ALT elevations or hepatotoxicity). 23812464
Peddi P, Lopez-Olivo MA, Pratt GF, Suarez-Almazor ME. Denosumab in patients with cancer and skeletal metastases: a systematic review and meta-analysis. Cancer Treat Rev 2013; 39: 97-104. (Systematic review of literature on efficacy and safety of denosumab in therapy of bone metastases; no mention of ALT elevations or hepatotoxicity). 22898302
Langdahl BL, Teglbjærg CS, Ho PR, Chapurlat R, Czerwinski E, Kendler DL, Reginster JY, et al. A 24-month study evaluating the efficacy and safety of denosumab for the treatment of men with low bone mineral density: results from the ADAMO trial. J Clin Endocrinol Metab 2015; 100: 1335-42. (Among 228 men with low bone mineral density treated with denosumab or placebo for 12 months who were then crossed over to an open label 12 month study, for up to 24 months, and, while serious adverse events occurred in 13 [6%] subjects, none were liver related or clearly related to denosumab and there was no me ntion of ALT elevations). 25607608
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to denosumab or other agents used to treat osteoporosis). 25754159
Papapoulos S, Lippuner K, Roux C, Lin CJ, Kendler DL, Lewiecki EM, Brandi ML, et al. The effect of 8 or 5 years of denosumab treatment in postmenopausal women with osteoporosis: results from the FREEDOM Extension study. Osteoporos Int 2015; 26: 2773-83. (Among 4550 postmenopausal women with osteoporosis treated with denosumab [every 6 months] for 5-8 years, adverse event rates were low and did not increase or change over time; no mention of ALT elevations or hepatotoxicity). 26202488
Stopeck AT, Fizazi K, Body JJ, Brown JE, Carducci M, Diel I, Fujiwara Y, et al. Safety of long-term denosumab therapy: results from the open label extension phase of two phase 3 studies in patients with metastatic breast and prostate cancer. Support Care Cancer 2016; 24: 447-55. (In an open label extension of a short term placebo controlled trial of denosumab for patients with breast or prostate cancer and bone metastases for 3-4 years, no new safety concerns arose and serious adverse events included osteonecrosis of the jaw [6-8%], infections [28-42%] and hypocalcemia [<1%], but there was no mention of ALT elevations or hepatotoxicity). 26335402
Bone HG, Wagman RB, Brandi ML, Brown JP, Chapurlat R, Cummings SR, Czerwiński E, et al. 10 years of denosumab treatment in postmenopausal women with osteoporosis: results from the phase 3 randomised FREEDOM trial and open-label extension. Lancet Diabetes Endocrinol 2017; 5: 513-23. (In a long term extension study after a randomized, placebo controlled trial [Cummings 2009], 4550 postmenopausal women with osteoporosis were treated for another 7 years with denosumab; serious adverse events included osteonecrosis of the jaw (n=13) and atypical fractures, but there was no mention of ALT elevations or hepatotoxicity). 28546097
Malnick S, Maor Y, Melzer E, Ziv-Sokolowskaia NN, Neuman MG. Severe hepatocytotoxicity linked to denosumab. Eur Rev Med Pharmacol Sci 2017; 21 (1 Suppl): 78-85. (72 year old woman with osteoporosis developed liver injury one month after a single, initial infusion of denosumab [bilirubin risng to 13.8 mg/dL, ALT ~1800 U/L, GGT ~750 U/L, INR 1.8], improving with corticosteroid therapy and relapsing when they were stopped; autoantibodies were negative at onset). 28379592

## OTHER REFERENCE LINKS

1. Recent References on Denosumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Denosumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Denosumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Denosumab)